# Flutamide

## OVERVIEW

### Introduction

Flutamide is a first generation, oral nonsteroidal antiandrogen that has been used widely in the therapy of prostate cancer. Flutamide is frequently associated with minor serum aminotransferase elevations and has been linked to numerous cases of acute liver injury, which are frequently severe and can be fatal.

### Background

Flutamide (floo' ta mide) is a synthetic, nonsteroidal antiandrogen that acts by competitive inhibition of the binding of testosterone and dihydrotestosterone to the intracellular androgen receptor, thus blocking the effects of endogenous androgen action. Flutamide acts by binding to and blocking intracellular androgen receptors in target tissues including not only the testes and prostate, but also skin and hair follicles. Flutamide was approved for use in therapy of prostate cancer in the United States in 1989 and has been extensively used around the world. Flutamide’s antiandrogen effects have also been applied to the therapy of hyperandrogenic states both in men and women, including acne, hirsutism and benign prostatic hypertrophy. Because of the potentially serious hepatotoxicity of flutamide, its use outside of therapy of malignant disease is no longer recommended. Newer antiandrogens with better tolerance and minimal or no risk of hepatotoxicity have been developed and largely replaced flutamide as therapy of prostatic cancer. The current indications for flutamide are limited to the treatment of prostate cancer in combination with a luteinizing hormone releasing hormone (LHRH) analog such as leuprolide or goserelin. Flutamide is available in generic forms and under the brand name of Eulexin in 125 mg capsules. The usual dose is 250 mg two to three times daily, usually in combination with other antiprostate cancer modalities such as orchiectomy or an LHRH analog. Common side effects of flutamide are rash, drowsiness, anxiety, gynecomastia and loss of libido.

### Hepatotoxicity

Chronic therapy with flutamide is associated with elevations in serum aminotransferase levels in up to 62% of patients, but marked elevations (above 5 times ULN) in only 3% to 5%. Most of these abnormalities are transient, asymptomatic and do not require dose adjustment or drug discontinuation. However, in 0.1% to 1% of patients, acute liver injury with symptoms and jaundice arises which can be prolonged, severe and even fatal. The latency of onset ranges widely from 1 to 10 months (Cases 2 and 3), averaging 3 months. Allergic manifestations are rare as are autoantibodies. The pattern of liver enzyme elevations is most commonly hepatocellular, but many cases with cholestatic and mixed patterns have been described. Liver failure with a requirement for emergency liver transplantation or fatality has been described in many publications with 20 fatal cases reported from the FDA MedWatch program during the first 5 years of its availability. Fatal cases have been reported in children and young women being treated for hirsutism or acne (Case 1).

Current recommendations for routine monitoring of liver tests include ALT levels monthly for the first 4 months of flutamide therapy and regularly thereafter with prompt discontinuation if ALT levels rise above twice ULN. Nevertheless, well characterized fatal cases have occurred despite such monitoring, the onset of injury being abrupt and injury continuing for several weeks after discontinuation of flutamide. The injury may be partially dose related as long term use of lower doses of flutamide (62.5 and 125 mg/day) has not been associated with high rates of ALT elevations or clinically apparent liver injury.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury due to flutamide is not clearly understood. Flutamide is extensively metabolized by the liver, and a common hypothesis is that flutamide is metabolized by the cytochrome P450 system (CYP 3A4) to a toxic intermediate.

### Outcome and Management

The mortality rate of flutamide hepatotoxicity is considerable, particularly in cases with a hepatocellular pattern of injury and in elderly men. Generally, the injury begins to resolve within 1 to 2 weeks of stopping therapy. In severe cases, there can be progressive worsening with development of hypoalbuminemia, edema, ascites, hepatic encephalopathy and coagulopathy. Some patients with acute liver failure due to flutamide have undergone successful liver transplantation, but the underlying diagnosis of prostate cancer usually excludes patients from consideration for transplantation. Chronic injury from flutamide has not been described, but long term follow up on patients with flutamide injury is rarely available. Rechallenge with flutamide generally causes recurrence of injury and should be avoided. Switching therapy to other androgens (bicalutamide or nilutamide) has not been reported, but several instances of recurrence of hepatic injury have been reported among patients switched from flutamide to cyproterone acetate. Because of its known hepatotoxicity, flutamide is used less frequently than in the past. Patients on flutamide should be monitored for liver test abnormalities on a regular basis, at least during the first 4 months of treatment.

Drug Class: Antineoplastic Agents, Antiandrogens

## CASE REPORTS

### Case 1. Liver failure in a 14 year old hirsute female following flutamide therapy.(1)

A 14 year old girl was treated with flutamide (250 mg twice daily) for hirsutism and presented with a 2 week history of weakness, poor appetite and dark urine 3 months later. Her past medical history was unremarkable. She had no known risk factors for viral hepatitis and was not taking other drugs or herbal medicines. On admission, she was jaundiced but not febrile and was fully alert without asterixis. Laboratory results showed total bilirubin of 7.3 mg/dL and marked elevations in serum aminotransferase levels (ALT 2372 U/L, AST 1707 U/L) and decrease in prothrombin index (29%). Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound was normal. Over the next few days, serum bilirubin levels rose to 17.5 mg/dL and she developed signs of hepatic encephalopathy. Because of a worsening clinical condition, she was transferred to a liver transplantation center and received a deceased donor liver graft 9 days later. The explanted liver showed massive necrosis. The liver transplantation was successful and she was discharged two months later.

#### Key Points

Medication: | Flutamide (250 mg twice daily)
Pattern: | Hepatocellular
Severity: | 5+ (liver transplantation)
Latency: | ~3 months
Recovery: | Required liver transplantation
Other medications: | None

#### Comment

There have been many case reports of acute liver failure attributable to flutamide therapy, but largely in elderly men being treated for metastatic prostate cancer. This case report and several like it demonstrate that acute liver failure from flutamide can occur in women as well as men, and in children and young adults as well as in the elderly. For this reason, this agent should be reserved for persons with medically severe or malignant conditions. The typical onset of flutamide associated liver injury is the abrupt appearance of jaundice after 2 to 3 months of therapy. Signs of hypersensitivity and autoimmunity are rare and serum enzymes usually demonstrate a markedly hepatocellular pattern. While the injury is rapidly reversible, the degree of injury may be such that hepatic failure occurs rapidly and is not reversible. Recently, studies of low and “ultra-low” doses of flutamide (62.5 to 250 mg daily) as therapy of hirsutism have been reported showing little or no evidence of hepatic injury (based upon ALT testing) during therapy for 12 months and longer. Nevertheless, the therapeutic window is narrow and neither flutamide or the other synthetic antiandrogens are approved for use in benign hyperandrogenic conditions in the United States.

### Case 2. Hepatitis and jaundice after flutamide therapy of prostate cancer.(2)

A 65 year old man with prostate cancer underwent bilateral orchidectomy and was started on flutamide (250 mg twice daily). Eight months later, he developed nausea and subsequently noted fatigue and jaundice. He was hospitalized and found to have fever, jaundice and hepatic tenderness. He had no previous history of liver disease and no risk factors for hepatitis or alcohol use. His other medical conditions included diabetes, coronary artery disease and hyperlipidemia. Laboratory tests showed a bilirubin of 24 mg/dL and marked elevations in serum aminotransferase levels with minimal increase in alkaline phosphatase (Table). Tests for hepatitis A, B, C, and E were negative as were autoantibodies. Liver imaging showed no evidence of obstruction. A liver biopsy showed intrahepatic cholestasis with mild inflammatory changes and no fibrosis, compatible with drug induced liver disease. Flutamide was stopped and he was treated with antibiotics and ursodiol. He improved slowly and remained jaundiced for several months. A one month course of corticosteroids was given with marked improvement in symptoms and jaundice. Four months after onset of illness he was off of corticosteroids and ursodiol and his liver tests had returned to normal.

#### Key Points

Medication: | Flutamide (250 mg twice daily)
Pattern: | Hepatocellular
Severity: | 4+ (jaundice, hospitalization and rise in INR above 1.5)
Latency: | 8 months (onset of nausea)
Recovery: | 4 months
Other medications: | Metformin, isosorbide mononitrate, amlodipine, simvastatin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Flutamide 250 mg twice daily started for prostate cancer
9 months | 0 | 646 | 114* | 24.0 | Albumin 4.3 g/dL
| 1 week | 348 | | 29.0
| 2 weeks | 242 | 146 | 33.5
| 3 weeks | 182 | 138 | 19.6
10 months | 4 weeks | 104 | 108 | 13.7 | Protime 16 sec
| 5 weeks | 68 | 150 | 11.3 | Corticosteroids started
| 6 weeks | 69 | 158* | 11.5
11 months | 8 weeks | 66 | | 3.5 | Corticosteroids stopped
12 months | 14 weeks | 18 | 76 | 0.5 | Asymptomatic
Normal Values | | <40 | <120 | <1.2

* Values adjusted to standard upper limit of normal.

#### Comment

A case of prolonged flutamide associated hepatitis arising after 9 months of therapy. The serum enzyme pattern of a 20-fold elevation in aminotransferase levels with minimal increase in alkaline phosphatase defines the case as “hepatocellular”, but the clinical course of the illness was decidedly cholestatic with severe jaundice and pruritus. While corticosteroids have not been proven to be beneficial in acute drug induced liver injury, they may alleviate symptoms and decrease bilirubin in some patients with prolonged cholestasis, as in this case. Importantly, the dose of corticosteroids was reduced rapidly and they were stopped within a month or two. The authors hypothesized that simvastatin may have added to the liver injury; but flutamide by itself has been clearly implicated in many instances of hepatotoxicity of similar severity. Regardless, in patients presenting with jaundice of unknown cause, it is prudent to withdraw all but the most necessary medications until recovery.

### Case 3. Acute hepatitis due to flutamide therapy.(3)

A 66 year old man with advanced prostate cancer developed jaundice 4 weeks after starting antiandrogen therapy with flutamide. He had a past medical history of essential hypertension and type 2 diabetes for which he had been taking candesartan (16 mg daily) and glyburide (3.5 mg daily) for several years. Prostate cancer was diagnosed by biopsy and was treated with hormonal ablation using flutamide (750 mg daily) and monthly injections of the LHRH analog goserelin. On admission, he was deeply jaundiced but had no rash, fever, or signs of hepatic decompensation. Laboratory testing showed serum bilirubin of 13.6 mg/dL, ALT 2160 U/L and alkaline phosphatase 900 U/L (Table). Tests for hepatitis A, B and C and for EBV infection were negative as were autoantibodies. Ultrasound of the abdomen showed no hepatic masses and no evidence of bile duct dilation. A liver biopsy showed intrahepatic cholestasis suggestive of drug induced liver injury. Flutamide was stopped on admission and he started to improve rapidly. In follow up 2 months later, all laboratory tests were normal. He was continued on therapy with goserelin.

#### Key Points

Medication: | Flutamide (250 mg twice daily)
Pattern: | Hepatocellular (R=16)
Severity: | 3+ (jaundice and hospitalization)
Latency: | One month (to onset of jaundice)
Recovery: | One month
Other medications: | Candesartan and glyburide chronically; goserelin for 4 weeks

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin (mg/dL) | Other
Flutamide 250 mg three times daily started for prostate cancer
4 weeks | 0 | 2160 | 900 | 13.6 | INR 81%, albumin 3.9
| 2 days | 1825 | 763 | 9.4 | Liver biopsy
| 5 days | 1470 | 540 | 4.4 | Prednisone for ~2 weeks
5 weeks | 7 days | 750 | 450 | 3.2
| 9 days | 600 | 420 | 2.6
| 12 days | 360 | 330 | 1.5
6 weeks | 2 weeks | 270 | 288 | 1.2
7 weeks | 3 weeks | 40 | 240 | 0.8
Normal Values | | <40 | <270 | <1.2

* Values estimated from figure and bilirubin converted from µmol to mg/dL.

#### Comment

Although the latency to onset of one month was somewhat short (the usual latency being 2-6 months), this case was otherwise quite typical with a hepatocellular pattern of serum enzyme elevations and rapid improvement with stopping therapy. Cases with a fulminant course usually show evidence of hepatic failure even on presentation, with prolonged prothrombin time accompanying the marked aminotransferase elevations.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flutamide – Generic, Eulexin®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=flutamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Flutamide | 13311-84-7 | C11-H11-F3-N2-O3

## CITED REFERENCES

1 Andrade RJ, Lucena MI, Fernández MC, Suarez F, Montero JL, Fraga E, Hidalgo F. (1999). Fulminant liver failure associated with flutamide therapy for hirsutism. Lancet.
2 Ashar U, Desai D, Bhaduri A. (2003). Flutamide-induced hepatotoxicity with possible potentiation by simvastatin. J Assoc Physicians India.
3 Lübbert C, Wiese M, Haupt R, Ruf BR. (2004). Internist (Berl).

## ANNOTATED BIBLIOGRAPHY

References updated: 15 March 2023

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, p. 699. (Expert review of hepatotoxicity published in 1999, mentions that flutamide has led to instances of severe hepatic necrosis and fulminant hepatic failure).
DeLeve LD. Flutamide. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier. 2013. pp. 559. (Textbook on drug induced liver injury mentions that flutamide has been implicate in at least 46 cases of severe liver injury with 20 fatalities).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics; discusses the role of androgen receptor blockers in prostate cancer including bicalutamide, flutamide and nilutamide).
Lund F, Rasmussen F. (1988). Flutamide versus stilboestrol in the management of advanced prostatic cancer. A controlled prospective study. Br J Urol. (In a prospective study comparing flutamide to DES, one of 20 flutamide treated patients developed "massive jaundice" within 1 month of starting [bilirubin and ALT not given, Alk P 3950 U/L], resolving within 2 months of stopping).
Hart W, Stricker BH. (1989). Flutamide and hepatitis. Ann Intern Med. (70 year old man with prostate cancer developed jaundice after 5 weeks of flutamide therapy [bilirubin 4.3 mg/dL, ALT 158 U/L, Alk P 1070 U/L], resolving within 3 weeks of stopping).
Møller S, Iversen P. (1989). Ugeskr Laeger. (Danish publication of cases later published in J Hepatol [Møller 1990] in English).
Coppéré H, Perraud Y, Gérard F, Jouffre C, David A, Barthélémy C, Audigier JC. (1990). Gastroenterol Clin Biol. (54 year old man with prostate cancer developed weakness after 6 months of flutamide therapy [bilirubin normal, ALT 4.2 times ULN, Alk P normal], levels returning to normal after stopping).
Møller S, Iversen P, Franzmann MB. (1990). Flutamide-induced liver failure. J Hepatol. (2 men, ages 60 and 69 years, with prostate cancer developed jaundice 15 and 2 weeks after starting flutamide [bilirubin 34.6 and 14.9 mg/dL, AST 778 and 56 U/L, Alk P 401 and 1202 U/L], one case with coma; both recovered within 2-3 months of stopping).
Pavone-Macaluso M, Cacciatore M, Daricello G, Pavone C, Serretta V. (1990). Carcinoma of the prostate. Guidelines for treatment: the role of antiandrogens. Ann N Y Acad Sci. (In an early experience with using flutamide and cyproterone in 22 patients, one required drug discontinuation because of “liver insufficiency” and ALT elevations).
Alperine M, Cohen L, Cocheton JJ, Lecomte I, Meyniel D. (1991). Presse Med. (65 year old man with prostate cancer developed jaundice 3 months after starting flutamide [bilirubin 9.6 mg/dL, ALT 10 times and Alk P 2 times ULN], developing ascites but improving rapidly once flutamide was stopped, with full recovery within 2 months).
Corkery JC, Bihrle W, McCaffrey JA, Whitcomb FF, Levy C, Ellis R. (1991). Flutamide-related fulminant hepatic failure. J Clin Gastroenterol. (59 year old man with prostate cancer developed jaundice 6 months after starting flutamide [bilirubin 28 mg/dL, AST 1887 U/L, Alk P 312 U/L], subsequently dying of progressive liver failure).
Dankoff JS. (1992). Near fatal liver dysfunction secondary to administration of flutamide for prostate cancer. J Urol. (66 year old man with prostate cancer developed jaundice 10 weeks after starting flutamide [bilirubin 17.4 mg/dL, ALT 1323 U/L], resolving 6 weeks after stopping).
Gomez JL, Dupont A, Cusan L, Tremblay M, Suburu R, Lemay M, Labrie F. (1992). Incidence of liver toxicity associated with the use of flutamide in prostate cancer patients. Am J Med. (Prospective study of 1091 patients with prostate cancer given flutamide, routine ALT monitoring found 4 [0.36%] patients with ALT >4 times ULN, one with jaundice [bilirubin 7.4 mg/dL, ALT 209 U/L, Alk P 640 U/L], all recovering after stopping).
Martínez Bruna MS, Velila Alcubilla JP, Abinzano M, Martínez Velasco C, García Mauriz ME, Urbieta Echezareta M. (1993). An Med Interna. (79 year old man with prostate cancer developed jaundice [bilirubin 3.2 mg/dL] within a month of starting flutamide with normal ALT, AST and Alk P and fall of bilirubin to normal within 4 weeks).
Rosman AS, Frissora-Rodeo C, Marshall AT, Reiter BP, Paronetto F. (1993). Cholestatic hepatitis following flutamide. Dig Dis Sci. (72 year old man with prostate cancer developed jaundice 3 months after starting flutamide [bilirubin 13.0 mg/dL, ALT 443 U/L, Alk P 3054 U/L], resolving within 6 months of stopping).
Wallace C, Lalor EA, Chik CL. (1993). Hepatotoxicity complicating flutamide treatment of hirsutism. Ann Intern Med. (20 year old woman developed jaundice and severe pruritus 6 weeks after starting flutamide for acne [bilirubin 15.3 rising to 28.0 mg/dL, ALT 1481 U/L, Alk P 180 U/L], resolving within 3 months of stopping).
Wysowski DK, Freiman JP, Tourtelot JB, Horton ML. (1993). Fatal and nonfatal hepatotoxicity associated with flutamide. Ann Intern Med. (Description of 19 cases of flutamide hepatotoxicity reported to FDA between 1989-91, mean latency 56 days, 16 had hyperbilirubinemia, 5 deaths; 2 detailed case reports of men with prostate cancer developing jaundice 2 and 3 months after starting flutamide and LHRH analog [bilirubin peak of 35.4 and 2.1 mg/dL, ALT 1841 and 1871 U/L]; one case fatal).
Caballería E, Aragó JV, Sanchís A. (1994). Med Clin (Barc). (78 year old man with prostate cancer developed symptoms and jaundice 1 month after starting flutamide [bilirubin 1.2 rising to 6.5 mg/dL, ALT 716 U/L, Alk P 203 U/L], rapid resolution upon stopping).
Dourakis SP, Alexopoulou AA, Hadziyannis SJ. (1994). Fulminant hepatitis after flutamide treatment. J Hepatol. (Two men, ages 70 and 84 years, with prostate cancer developed jaundice 13 and 8 weeks after starting flutamide [bilirubin 17.7 and 25.2 mg/dL, ALT 768 and 473 U/L, Alk P 239 and 165 U/L with hepatic failure], slowly resolving in one and fatal outcome in the other [with massive necrosis on autopsy]; one case had abnormal and one had normal ALT levels during routine monitoring 4 weeks before presentation).
Prattichizzo FA. (1994). Acute cholestatic hepatitis secondary to flutamide therapy. Am J Med. (Elderly man with prostate cancer developed jaundice 12 weeks after starting flutamide [bilirubin 16.7 mg/dL, ALT 1204 U/L, Alk P 341 U/L], resolving within 2 months of stopping).
Kosar Y, Sasmaz N, Oguz P, Küçükbas S. (1995). Hepatic insufficiency developing as a result of flutamide treatment. Am J Gastroenterol. (58 year old man with prostate cancer developed jaundice 6 weeks after starting flutamide [bilirubin 11 mg/dL, ALT 348 U/L, Alk P 276 U/L, protime 34% and ascites], nevertheless, recovering within one month of stopping).
Moghetti P, Castello R, Negri C, Tosi F, Magnani CM, Fontanarosa MC, Armanini D, et al. (1995). Flutamide in the treatment of hirsutism: long-term clinical effects, endocrine changes, and androgen receptor behavior. Fertil Steril. (18 women with hirsutism were treated with flutamide [125 mg/day] for 12 months; one developed asymptomatic rise in ALT [without jaundice] at 8 months [peak value ~140 U/L], falling promptly with stopping).
Andréjak M, Nguyen-Khac E, Decocq G, Capron JP. (1996). Gastroenterol Clin Biol. (70 year old man with prostate cancer developed jaundice 10 weeks after starting flutamide [bilirubin 10 times and ALT 49 times ULN], later developing ascites, encephalopathy and dying 6 weeks after presentation).
Cicognani C, Malavolti M, Morselli-Labate AM, Sama C, Barbara L. (1996). Flutamide-induced toxic hepatitis. Potential utility of ursodeoxycholic acid administration in toxic hepatitis. Dig Dis Sci. (83 year old man with prostate cancer developed jaundice 7 months after starting flutamide [bilirubin 24.5 mg/dL, ALT 1340 U/L, Alk P 319 U/L], resolving within 6 weeks off stopping with ursodiol treatment).
Crownover RL, Holland J, Chen A, Krieg R, Young BK, Roach M, Fu KK. (1996). Flutamide-induced liver toxicity including fatal hepatic necrosis. Int J Radiat Oncol Biol Phys. (Case reports of 3 men with prostate cancer receiving flutamide; 78 year old developed jaundice 2 months after starting [bilirubin 24.3 mg/dL, ALT 759 U/L and, Alk P 141 U/L] with fatal outcome; 63 and 70 year olds found to have abnormal liver tests 5 and 6 weeks after starting [bilirubin 0.8 and 1.1 mg/dL, ALT 258 and 77 U/L, Alk P 70 and 120 U/L], subsequent rapid recovery upon stopping).
Lee HW, Chung JP, Lee KS, Kim KC, Lee KS, Chon CY, Park IS, Kim HG. (1996). A case of flutamide-induced acute cholestatic hepatitis--a case report. Yonsei Med J. (75 year old man with prostate cancer developed jaundice 7 months after starting flutamide [bilirubin 6.5 mg/dL, ALT 315 U/L, Alk P 470 U/L], resolving within 2 months of stopping).
Patel H, Rhee E, Zimmern PE. (1996). J Urol (Paris). (77 year old man with metastatic prostate cancer developed progressive fatigue, jaundice and confusion 1 month after starting flutamide [bilirubin 17 mg/dL, ALT 2,280 U/L], but with rapid improvement in mental status after stopping flutamide and normal values 6 months later while still on leuprolide).
Rosenthal SA, Linstadt DE, Leibenhaut MH, Andras EJ, Brooks CP, Stickney DR, Chang GC, et al. (1996). Flutamide-associated liver toxicity during treatment with total androgen suppression and radiation therapy for prostate cancer. Radiology. (Prospective study of liver tests in 65 prostate cancer patients given flutamide and goserelin for 4 months; ALT rose above normal in 62%, and to >5 times ULN in 7%; 14 patients stopped therapy early because of ALT levels; 2 patients developed hepatitis [bilirubin 3.9 and 3.8 mg/dL, ALT 1116 and 816 U/L], all resolved within 3 months of stopping).
Wysowski DK, Fourcroy JL. (1996). Flutamide hepatotoxicity. J Urol. (Review of flutamide events reported to FDA MedWatch 1989-1994, found 20 deaths and 26 hospitalizations for flutamide hepatotoxicity ~3/10,000; autopsy in 6 showed massive necrosis, mean onset of 3 months after starting; found 16 cases in literature).
Cantalejo Moreira M, García Espinosa V, Martín Gutiérrez JC, García Puig J. (1997). Med Clin (Barc). (82 year old man with prostate cancer developed jaundice 6 months after starting flutamide [bilirubin 22.7 mg/dL, ALT 686 U/L, Alk P 691 U/L], with rapid recovery within 1 month of stopping).
Fernández Peña CM, Morano Amado LE, Montes Santiago J, Fachal C. (1997). Med Clin (Barc). (68 year old man with metastatic prostate cancer developed jaundice 3 months after starting flutamide and LHRH analog therapy [bilirubin 17.4 mg/dL, ALT 1429 U/L, Alk P 8679 U/L, protime 66%]; despite stopping therapy promptly, he developed liver failure and died within a month of presentation).
García-Gascó P, Morata Aldea C, Segura Huertas A, Aparicio Urtasun J. (1997). Med Clin (Barc). (80 year old man with prostate cancer developed jaundice 4 months after starting flutamide therapy [bilirubin 27 mg/dL, ALT 781 U/L, Alk P 590 U/L, protime 41%]; rapid progression despite stopping drug to liver failure and death within 15 days).
Guzmán Martínez-Valls PL, Ferrero Doria R, Morga Egea JP, Ros R, Galiano R, Gutierrez A, Franco G, et al. (1997). Actas Urol Esp.
McLeod DG. (1997). Tolerability of nonsteroidal antiandrogens in the treatment of advanced prostate cancer. Oncologist. (Overview of the safety and side effects of the nonsteroidal antiandrogens; ALT elevations arise in 4-62% receiving flutamide; in comparison studies, 12% with flutamide vs 3% with placebo and 10% vs 6% with bicalutamide; clinically apparent hepatitis can occur and can be fatal; estimated rates being 3/10,000 treated).
Satoh T, Egawa S, Katsuta M, Iwamura M, Uchida T, Koshiba K. (1997). Nippon Hinyokika Gakkai Zasshi. (Abstract only: 66 year old man with metastatic prostate cancer developed jaundice 7 weeks after starting flutamide [375 mg/day], resolving within 2 months of stopping).
Wietzke P, Münke H, Hartmann H, Ramadori G. (1997). Z Gastroenterol. (Two cases of jaundice in men, ages 76 and 64 years, with prostate cancer given flutamide for 16 and 8 weeks [bilirubin 8.9 and 8.4 mg/dL, ALT 699 and 612 U/L, Alk P 206 and 241 U/L, one patient with ascites], resolving within 9-10 weeks of stopping).
Chu CW, Hwang SJ, Luo JC, et al. (1998). Flutamide-induced liver injury: a case report. Zhonghua Yi Xue Za Zhi (Taipei). (72 year old man with prostate cancer developed jaundice 5 months after starting flutamide [bilirubin 7.0 mg/dL, ALT 1035 U/L, Alk P 145 U/L], resolving within 3 months of stopping).
Cuevas Campos MA, Pareja Llorens G, García Romero E, Bertomeu Blanch F. (1998). Gastroenterol Hepatol. (67 year old man with prostate cancer developed jaundice 2 months after starting flutamide [bilirubin 11.2 mg/dL, ALT 1050 U/L, Alk P 381 U/L], resolving promptly upon stopping).
Mena FJ, Goyeneche ML, Velicia R, González JM, Bellido J, Caro-Patón A. (1998). Rev Esp Enferm Dig. (Two men, ages 77 and 69 years, with prostate cancer treated with flutamide and leuprolide for 4-5 months presented with jaundice [bilirubin 9.7 and 6.0 mg/dL, ALT 1058 and 1073 U/L, Alk P 620 and 459 U/L], resolving within 7 to 8 weeks of stopping).
Pogromov AP, Popova AM. (1998). Klin Med (Mosk).
Pontiroli L, Sartori M, Pittau S, Morelli S, Boldorini R, Albano E. (1998). Flutamide-induced acute hepatitis: investigation on the role of immunoallergic mechanisms. Ital J Gastroenterol Hepatol. (69 year old man with prostate cancer developed jaundice 4 months after starting flutamide therapy [bilirubin 14.1 mg/dL, ALT 946 U/L, Alk P 352 U/L], resolving rapidly upon stopping; tests for antibodies to flutamide-treated rat microsomes were negative).
Andrade RJ, Lucena MI, Fernández MC, Suarez F, Montero JL, Fraga E, Hidalgo F. (1999). Fulminant liver failure associated with flutamide therapy for hirsutism. Lancet. (14 year old girl developed jaundice 3 months after starting therapy with flutamide for acne [bilirubin 7.3 mg/dL, ALT 2372 U/L], with subsequent liver failure requiring transplantation; explant showed massive necrosis: Case 1).
Cetin M, Demirci D, Unal A, Altinbas M, Güven M, Unlühizarci K. (1999). Frequency of flutamide induced hepatotoxicity in patients with prostate carcinoma. Hum Exp Toxicol. (Prospective study of 22 patients with prostate cancer; two patients [9%] developed jaundice 5 and 8 weeks after starting flutamide [bilirubin 3.0 and 9.6 mg/dL, ALT 380 and 284 U/L, Alk P 1289 and 864 U/L]; one resolving within 4 weeks of stopping, the second being fatal).
Falsetti L, Gambera A, Legrenzi L, Iacobello C, Bugari G. (1999). Comparison of finasteride versus flutamide in the treatment of hirsutism. Eur J Endocrinol. (Controlled trial of finasteride [5 mg/day] vs flutamide [500 mg/day] for 12 months in 110 women with hirsutism; 2 patients on flutamide [4%] developed ALT elevations after 6 months, both resolving with stopping).
Nakagawa Y, Koyama M, Matsumoto M. (1999). Hinyokika Kiyo. (Case report of severe hepatotoxicity after 11 weeks of flutamide therapy associated with high levels of metabolites; among 37 men with prostate cancer treated with flutamide, minor ALT elevations occurred in 7 [19%], rapidly resolving; >100 U/L in 2 patients).
Nicolás D. (1999). Pérez-EbrI ML, Sarrión JV, Nos P. Gastroenterol Hepatol. (73 year old man with prostate cancer developed jaundice 10 months after starting flutamide and an LHRH analog [bilirubin 6.7 mg/dL, ALT 697 U/L, Alk P 164 U/L, protime 45% and mild ascites], resolving within 3-5 months of stopping).
Okaneya T, Murata Y, Kinebuchi Y. (1999). Nippon Hinyokika Gakkai Zasshi. (73 year old man with prostate cancer developed flutamide hepatotoxicity [ALT 3045 U/L] and died of complications of duodenal ulcer bleeding [abstract only]).
Pu YS, Liu CM, Kao JH, Chen J, Lai MK. (1999). Antiandrogen hepatotoxicity in patients with chronic viral hepatitis. Eur Urol. (Retrospective study of 121 men receiving antiandrogen therapy with flutamide or cyproterone found abnormal ALT levels in most or all who were HBsAg or anti-HCV-positive; but many were not tested, and frequency of ALT monitoring was unclear. Authors propose that antiandrogen hepatotoxicity is more frequent among men with preexisting hepatitis, but no attempt was made to separate hepatotoxicity from exacerbation of underlying disease).
Wada T, Ueda M, Abe K, Kobari T, Yamazaki H, Nakata J, Ikemoto I, et al. (1999). Hinyokika Kiyo. (Among 123 men with prostate cancer treated with flutamide, 33 [26%] developed "liver disorders;" rate was higher in those with previous histories of liver disease and preexisting elevations in GGT or ALT [abstract only]).
Ikemoto I, Ohishi Y, Yamazaki H, Wada T, Aizawa Y. (2000). Nippon Hinyokika Gakkai Zasshi. (Prospective study of ALT elevations in 50 patients with prostate cancer receiving flutamide; 12 patients developed abnormalities which were severe in 2 [4%] and with only mild bilirubin elevations [abstract only]).
Román Llorente FJ, Alvarez Navascués C, Suárez González A, González Bernal AC. (2000). Gastroenterol Hepatol. (23 year old woman treated with flutamide [500 mg/day] for hirsutism for 5 months developed jaundice [bilirubin 26.6 mg/dL, ALT 1268 U/L, Alk P 119 U/L], resolving within 3 months of withdrawal).
García Cortés M, Andrade RJ, Lucena MI, Sanchez Martinez H, Fernandez MC, Ferrer T, Martin-Vivaldi R, et al. (2001). Flutamide-induced hepatotoxicity: report of a case series. Rev Esp Enferm Dig. (Spanish registry from 1994-2000 contained 9 cases [5%] of flutamide hepatotoxicity; 8 were men, mean age 75 years, no autoantibodies, no eosinophilia, latency to onset of 4 to 433 days [mean=151 days], usually with hepatocellular pattern of enzyme elevations; 2 deaths).
Kraus I, Vitezic D, Oguic R. (2001). Flutamide-induced acute hepatitis in advanced prostate cancer patients. Int J Clin Pharmacol Ther. (3 cases of jaundice arising 20-22 weeks after starting flutamide therapy for prostate cancer [bilirubin 16.8, 24.6 and 10 mg/dL, ALT 750, 670 and 854 U/L, Alk P 158, 411 and 238 U/L], all 3 resolving within 2 months of stopping).
Ruiz R, Casañ R, Juan O. (2001). Aten Primaria. (74 year old man with prostate cancer developed jaundice 6 months after starting flutamide [bilirubin 11.1 mg/dL, ALT 806 U/L, GGT 689 U/L], severe course but ultimately resolved).
Ruiz-Rebollo M, Atienza-Sánchez R, López-García E. (2001). Gastroenterol Hepatol. (23 year old woman with hirsutism treated with flutamide [500 mg/day] for 4 months developed abdominal pain and jaundice [bilirubin 22.4 mg/dL, ALT 1618 U/L, Alk P 422 U/L], relapsing upon inadvertent reintroduction of flutamide [bilirubin rising to 46.7 mg/dL, ALT 965 U/L, Alk P 459 U/L], but then resolution within 4 months of stopping).
Venturoli S, Paradisi R, Bagnoli A, Colombo FM, Ravaioli B, Vianello F, Mancini F, et al. (2001). Low-dose flutamide (125 mg/day) as maintenance therapy in the treatment of hirsutism. Horm Res. (Trial of flutamide [250 for 12 months followed by 125 mg/day for 12 months] in 47 women with hirsutism found ALT elevations in 4 [9%] during first 2 months, thereafter no further ALT elevations or liver toxicity observed).
Ozono S, Yamaguchi A, Mochizuki H, Kawakami T, Fujimoto K, Otani T, Yoshida K, et al. (2002). Caffeine test in predicting flutamide-induced hepatic injury in patients with prostate cancer. Prostate Cancer Prostatic Dis. (Study of patients who received flutamide for prostate cancer found that the 9 with ALT elevations had decreased caffeine metabolism compared to 2 who did not, suggesting a role for CYP1A2).
Aizawa Y, Ikemoto I, Kishimoto K, Wada T, Yamazaki H, Ohishi Y, Kiyota H, et al. (2003). Flutamide-induced hepatic dysfunction in relation to steady-state plasma concentrations of flutamide and its metabolites. Mol Cell Biochem. (Prospective study of 55 patients with prostate cancer treated with flutamide, found higher levels of metabolite [FLU-1] in 2 patients who developed hepatotoxicity compared to others).
Ashar U, Desai D, Bhaduri A. (2003). Flutamide-induced hepatotoxicity with possible potentiation by simvastatin. J Assoc Physicians India. (65 year old man with prostate cancer developed jaundice 8-9 months after starting flutamide [bilirubin 24 mg/dL, ALT 646 U/L, Alk P 290 U/L]; jaundice lasted 2 months but ultimately there was full recovery within 4 months of stopping: Case 2).
Famularo G, De Simone C, Minisola G, Nicotra GC. (2003). Flutamide-associated acute liver failure. Ann Ital Med Int. (74 year old man with prostate cancer developed jaundice 2 months after starting flutamide [bilirubin 26 mg/dL, ALT 2372 U/L, Alk P 3 times ULN, INR 2.3 and ascites], resolving slowly and incompletely over the next 10 months).
Kackar RR, Desai HG. (2003). Hepatic failure with flutamide. Indian J Gastroenterol. (41 year old woman with hair loss developed fever and jaundice 3 months after starting flutamide [bilirubin 2.3 rising to 24.4 mg/dL, ALT 1800 U/L, Alk P 183 U/L, rising INR, ascites and coma], but ultimately recovering spontaneously without transplantation).
Lin AD, Chen KK, Lin AT, Chang Y-H, Wu HHH, Kuo J-Y, Huang WJS, et al. (2003). Antiandrogen-associated hepatotoxicity in the management of advanced prostate cancer. J Chin Med Assoc. (Retrospective review of 229 patients with prostate cancer treated with flutamide or cyproterone and a LHRH agonist, orchiectomy or radiotherapy with regular monitoring of ALT; ALT >2 times ULN arose in 15.3% of flutamide and 9.5% of cyproterone treated subjects; ALT >6 times ULN in 5% vs 4%; no deaths, a few had jaundice).
Takashima E, Iguchi K, Usui S, Yamamoto H, Hirano K. (2003). Metabolite profiles of flutamide in serum from patients with flutamide-induced hepatic dysfunction. Biol Pharm Bull. (Analysis of metabolic products of flutamide; pattern found to be similar in patients with and without ALT elevations).
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. (2004). Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but no case was attributed to an antiandrogen, perhaps because patients with prostate cancer were less likely to be eligible for liver transplantation).
Lübbert C, Wiese M, Haupt R, Ruf BR. (2004). Internist (Berl). (77 and 66 year old men with prostate cancer developed jaundice 4 and 12 weeks after starting flutamide [bilirubin 13.6 and 25 mg/dL, ALT 1825 and 2145 U/L, Alk P 1.5 and 3 times ULN], one resolving within 4 weeks of stopping and the other progressing to liver failure and death: Case 3).
Manolakopoulos S, Bethanis S, Armonis A, Economou M, Avgerinos A, Tzourmakliotis D. (2004). Toxic hepatitis after sequential administration of flutamide and cyproterone acetate. Dig Dis Sci. (76 year old man with prostate cancer developed jaundice 6 months after starting flutamide [bilirubin 23.6 mg/dL, ALT 164 U/L, Alk P 132 U/L], which recurred 5 months after switching to cyproterone [bilirubin 6.8 mg/dL, ALT 162 U/L, Alk P 302], having a similar time course of recovery).
Thole Z, Manso G, Salgueiro E, Revuelta P, Hidalgo A. (2004). Hepatotoxicity induced by antiandrogens: a review of the literature. Urol Int. (Systematic review of the literature from the Spanish pharmacovigilance group; 21 reports of hepatotoxicity on cyproterone, 46 flutamide, 4 nilutamide and only 1 bicalutamide; 6 cases of hepatocellular carcinoma linked to cyproterone therapy).
Vázquez Romero M, Gil Grande L, López Serrano P, Alemán Villanueva S, García Plaza A. (2004). An Med Interna. (82 year old man with prostate cancer developed jaundice 2-3 months after starting flutamide and leuprolide [bilirubin 13.6 mg/dL, ALT 1369 U/L, GGT 586 U/L], with rapid recovery upon stopping).
Bengoechea Gallastegui L, Vita Garay A, Castiella Eguzkiza A, Egido Arroyo JF. (2005). Aten Primaria. (68 year old man with prostate cancer and HBsAg carrier state [HBV DNA 10,100 copies/mL, HBeAg negative] developed elevated ALT [1474 U/L] and GGT [540 U/L] 30 weeks after starting flutamide therapy, rapid recovery upon stopping; no mention of jaundice).
Ibáñez L, Jaramillo A, Ferrer A, de Zegher F. (2005). Absence of hepatotoxicity after long-term, low-dose flutamide in hyperandrogenic girls and young women. Hum Reprod. (Prospective study of long term flutamide in doses of 62.5, 125 and 250 mg daily in 190 women with hirsutism, found no ALT elevations during routine screening, suggesting that flutamide hepatotoxicity is partially dose related).
Legro RS. (2006). Long-term, low-dose flutamide does not cause hepatotoxicity in hyperandrogenic women. Nat Clin Pract Endocrinol Metab. (Editorial on study by Ibanez [2005] expressing caution about using flutamide particularly in view of potential of fetal toxicity in young women).
Papaioannides D, Korantzopoulos P, Bouropoulos C, Latsi P, Fotinou M, Orphanidou D. (2005). Microscopic polyangiitis complicated by the development of prostate cancer and flutamide-induced hepatitis. Int Urol Nephrol. (65 year old man on long term cyclophosphamide developed prostate cancer and then became jaundiced 6 months after starting flutamide [bilirubin 12.5 mg/dL, ALT 480 U/L, Alk P 410 U/L], resolving within 6 weeks of stopping; later developed gastric cancer).
Ramírez R, Ruiz MA, Auguet T, Richart C. (2005). Gastroenterol Hepatol. (91 year old man developed jaundice and confusion 6 months after starting flutamide for prostatism [bilirubin 9.4 mg/dL, ALT 342 U/L, GGT 223 U/L, ammonia 420 μmol/L], but with ultimate full recovery within 6 weeks of stopping).
Manso G, Thole Z, Salgueiro E, Revuelta P, Hidalgo A. (2006). Spontaneous reporting of hepatotoxicity associated with antiandrogens: data from the Spanish pharmacovigilance system. Pharmacoepidemiol Drug Saf. (Analysis of spontaneous reporting to Spanish Pharmacovigilance system found 88 cases of flutamide, 11 bicalutamide and 15 cyproterone hepatotoxicity, latency 3-6 months; 2 fatalities, both from flutamide).
Björnsson E, Olsson R. (2006). Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports; flutamide ranked 11th with a total of 59 cases).
Osculati A, Castiglioni C. (2006). Fatal liver complications with flutamide. Lancet. (18 year old woman developed jaundice 5 months after starting flutamide therapy of acne [bilirubin 13 rising to 32 mg/dL, ALT 4717 U/L, GGT 140 U/L], with progressive hepatic failure, liver transplantation but death in perioperative period due to sepsis).
Miquel M, Soler A, Vaqué A, Ojanguren I, Costa J, Planas R. (2007). Suspected cross-hepatotoxicity of flutamide and cyproterone acetate. Liver Int. (78 year old man with prostate cancer developed jaundice 3 months after starting flutamide [bilirubin 20.9 mg/dL, ALT 262 U/L, Alk P 104 U/L], resolving upon stopping, but recurring within 2 months of switching to cyproterone [bilirubin 15.6 mg/dL, ALT 373 U/L, Alk P 70 U/L], similar course of recovery).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, none were attributed to an antiandrogen).
Castelo Branco C, Moyano D, Gomez O, Balasch J. (2009). Long-term safety and tolerability of flutamide for the treatment of hirsutism. Fertil Steril. (Prospective study of use of flutamide with or without estrogens in 83 women with hirsutism; side effects were common, two women developed ALT elevations but no details given).
Wang YP, Shi B, Chen YX, Xu J, Jiang CF, Xie WF. (2009). Drug-induced liver disease: an 8-year study of patients from one gastroenterological department. J Dig Dis. (Among 30 patients with drug induced liver injury seen at a single medical center in Beijing between 2000 and 2007, one case was due to flutamide; ALT 8 times ULN, Alk P normal, bilirubin 12.7 mg/dL arising 12 weeks after starting drug).
Dikensoy E, Balat O, Pence S, Akcali C, Cicek H. (2009). The risk of hepatotoxicity during long-term and low-dose flutamide treatment in hirsutism. Arch Gynecol Obstet. (Prospective trial of 12 month course of low dose flutamide [50-250 mg/day], with ALT monitoring every 3 months in 214 women with hirsutism; none developed abnormal ALT or AST).
de Zegher F, Ibáñez L. (2009). Low-dose flutamide for women with androgen excess: anti-androgenic efficacy and hepatic safety. J Endocrinol Invest. (Opinion article suggesting that low dose flutamide [62.5-125 mg/day] can be safely and effectively used to treat hirsutism and acne in women with androgen excess, no ALT elevations having been reported in 286 women on 62.5 mg and 166 on 125 mg daily for at least 12 months).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiandrogen therapies).
Paradisi R, Venturoli S. (2010). Retrospective observational study on the effects and tolerability of flutamide in a large population of patients with various kinds of hirsutism over a 15-year period. Eur J Endocrinol. (Among 414 women with hirsutism treated with flutamide in yearly decreasing doses, 25 [6%] developed ALT elevations, all without jaundice or symptoms, usually mild, arising during first year of therapy while on 250 mg/day, resolving rapidly on stopping).
Paradisi R, Fabbri R, Porcu E, Battaglia C, Seracchioli R, Venturoli S. (2011). Retrospective, observational study on the effects and tolerability of flutamide in a large population of patients with acne and seborrhea over a 15-year period. Gynecol Endocrinol. (Among 230 women with acne treated with flutamide in yearly reducing doses, 11 [4.8%] discontinued therapy because of ALT elevations, all during the first year while on 250 mg/day, all resolving upon stopping treatment).
Paradisi R, Porcu E, Fabbri R, Seracchioli R, Battaglia C, Venturoli S. (2011). Prospective cohort study on the effects and tolerability of flutamide in patients with female pattern hair loss. Ann Pharmacother. (Among 101 women with female pattern hair loss treated with flutamide for up to 4 years, 4 [4%] discontinued therapy because of ALT elevations during the first year, but none for this reason in subsequent years when lower doses were used [125 and 62.5 mg/day], ALT elevations resolving rapidly after stopping in all).
Brahm J, Brahm M, Segovia R, Latorre R, Zapata R, Poniachik J, Buckel E, Contreras L. (2011). Acute and fulminant hepatitis induced by flutamide: case series report and review of the literature. Ann Hepatol. (Analysis of 10 patients with flutamide hepatotoxicity seen at a single institution in Chile included 3 men [ages 67-80 with prostate cancer] and 7 women [ages 20-44 with hirsutism], onset in 40-180 days, 9 with jaundice [bilirubin 2.4-44 mg/dL, ALT 159-3360 U/L], 5 progressed to acute liver failure requiring liver transplantation [all women]).
Bruni V, Peruzzi E, Dei M, Nannini S, Seravalli V, Sisti G, Fambrini M. (2012). Hepatotoxicity with low- and ultralow-dose flutamide: a surveillance study on 203 hyperandrogenic young females. Fertil Steril. (Among 203 young women with polycystic ovary syndrome treated with low doses of flutamide [62.5 or 125 mg/day] for up to 5 years, ALT or AST elevations [43-509 U/L] occurred in 9% during the first year [arising after 2 to 48 weeks], with resolution within 4 weeks of stopping in all; no mention of jaundice or symptoms).
Karaahmet F, Kurt K. (2012). Hepatotoxicity with flutamide. Fertil Steril. (Letter in response to Bruni [2012] raising issue of definition of hepatotoxicity).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to bicalutamide, but none to other antiandrogens such as flutamide).
Choudhary NS, Saigal S, Saraf N, Rastogi A, Goja S, Bhangui P, Vohra V, et al. (2017). Good outcome of living donor liver transplantation in drug-induced acute liver failure: A single-center experience. Clin Transplant. (Among 1396 adult living donor liver transplants done at a single referral center in India, 64 were done for acute liver failure including 18 caused by drugs; 14 by antituberculosis medications, 1 flutamide, 1 orlistat and 2 herbal supplements).
Castelo-Branco C, Hernández-Angeles C, Alvarez-Olivares L, Balasch J. (2016). Long-term satisfaction and tolerability with low-dose flutamide: a 20-year surveillance study on 120 hyperandrogenic women. Gynecol Endocrinol. (Among 120 women with hyperandrogenism treated with flutamide [125 or 250 mg daily] for up to 20 years, 11 stopped therapy because of ALT abnormalities and one for acute fatty liver requiring hospitalization; timing and degree of abnormalities not provided).
Crawford ED, Schellhammer PF, McLeod DG, Moul JW, Higano CS, Shore N, Denis L, et al. (2018). Androgen receptor targeted treatments of prostate cancer: 35 years of progress with antiandrogens. J Urol. (Review of the development of antiandrogen therapies of prostate cancer starting with discovery of the androgen sensitive nature of prostate cancer, the effects of orchiectomy, followed by the development of androgen receptor antagonists, first generation agents flutamide and nilutamide, second generation agent bicalutamide and third generation agents enzalutamide, apalutamide and darolutamide that have more potent androgen receptor inhibition).

## OTHER REFERENCE LINKS

1 Recent References on Flutamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=flutamide/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222009/01/01%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Flutamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=flutamide)